# Semaglutide

## OVERVIEW

### Introduction

Semaglutide is a recombinant DNA produced polypeptide analogue of human glucagon-like peptide-1 (GLP-1) which is used in combination with diet and exercise in the therapy of type 2 diabetes either alone or in combination with other antidiabetic agents and more recently in weight loss therapy for adults who are overweight or obese. There have been rare published reports of hepatotoxicity attributed to semaglutide therapy.

### Background

Semaglutide (sem" a gloo' tide) is a glucagon-like peptide-1 (GLP-1) analogue (also called a GLP-1 receptor agonist) that acts like the native gastrointestinal hormone (an incretin) to increase insulin secretion. Semaglutide is a recombinant DNA-produced polypeptide that is 94% homologous to endogenous human GLP-1(7-37) and differs only by minor amino acid substitutions and other structural modifications, which prolong its half-life and make it resistant to degradation by dipeptidyl peptidase 4 (DPP4). Semaglutide, like other GLP-1 analogues, is given parenterally, but its long half-life allows weekly dosing. Semaglutide has been shown to improve glycemia control in patients with type 2 diabetes was approved as an adjunct to diet and exercise for use use in the United States in 2017 under the brand name Ozempic, the sixth GLP-1 receptor agonist to be approved for treatment of diabetes. Indications for Ozempic were later expanded to include reduction of the risk of major adverse cardiovascular events and risk of end-stage kidney disease in patients with type 2 diabetes and established cardiovascular or chronic kidney disease disease. Semaglutide is available in single-patient-use, multi-dose pens of 2, 4 and 8 mg in 3 mL. The recommended starting dose is 0.25 mg by subcutaneous injection once weekly with subsequent increases at 4-week intervals to 0.5 and then 1 mg once weekly.

Recent studies indicated that semaglutide is absorbed orally to some degree and high doses (7 to 14 mg) are as effective as parenteral doses (0.25 to 1.0 mg) in improving glycemic control and inducing weight loss. Oral semaglutide was approved as an adjunct to diet and exercise for treatment of type 2 diabetes in 2024 under the brand name Rybelsus. Rybelsus is available in two formulations: R1 in tablets of 3, 7, and 14 mg, and R2 as tablets of 1.5, 4 and 9 mg. The starting dose for R1 is 3 mg, and for R2 is 1.5 mg daily for the first 30 days followed by dose escalations at 30-day intervals to as high as 14 for R1 and 9 mg daily for R2.

Semaglutide also causes weight loss particularly when given in high doses. Semaglutide appears to cause weight loss by decreasing hunger and increasing satiety as well as by delaying gastric emptying. Weight loss can be profound resulting in a 10-15% decline in body weight. Relapse is common when semaglutide is discontinued and its long-term safety and efficacy remain uncertain. Semaglutide was approved as a weight loss agent for persons who are overweight or obese in 2021 under the brand name Wegovy. Since initial approval, indications for Wegovy have been expanded to include children with obesity who are above the age of 12 years and for overweight or obese adults with established cardiovascular disease to reduce the risk of major adverse cardiovascular events. For all indications it is described as an adjunct to diet and exercise. For weight loss, semaglutide is available in prefilled single dose pens that deliver doses of 0.25, 0.5, 1.0, 1.7 and 2.4 mg. The usual starting dose is 0.25 mg by subcutaneous injection once weekly, which can be increased at 4-week intervals to 0.5, 1.0, 1.7 and 2.4 mg weekly based upon efficacy and tolerance.

Semaglutide is moderately well tolerated, but side effects can be dose limiting and include injection site reactions, diarrhea, nausea, vomiting, abdominal pain, dizziness, headache, fatigue and hypoglycemia. Rare potential adverse events include pancreatitis, thyroid C-cell tumors, and hypersensitivity reactions. Recently, long-term semaglutide therapy (greater than 2 years) has been linked to ischemic optic neuropathy particularly in persons with diabetes and hypertension.

### Hepatotoxicity

In large clinical trials, serum enzyme elevations were no more common with semaglutide therapy than with placebo or comparator agents, and no instances of clinically apparent liver injury were reported. Indeed, treatment with semaglutide and other GLP-1 analogues was usually associated with improvements in serum aminotransferase levels (and hepatic steatosis) making them possible treatments for nonalcoholic fatty liver. Since licensure, there have been rare, published case reports of hepatotoxicity attributed to oral and parenteral semaglutide with a prolonged cholestatic course. At least ten cases of hepatic injury attributable to semaglutide have been reported to the FDAs Adverse Event Reporting System (FAES). The FAES database has many instances of hepatobiliary complications attributed to GLP-1 agonists. Most of these reports, however, relate to gallstones and complications of cholecystitis and choledocholithiasis rather than hepatic injury. Furthermore, the increased rate of gallstone complications is probably due to the weight loss caused by the drug rather than a direct effect of the GLP-1 agonist on the biliary system. The product label for semaglutide does not list liver injury as an adverse event. Thus, liver injury due to semaglutide may occur but is very rare.

Likelihood score: D (possible cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the rare cases of hepatic injury attributed to semaglutide is unknown. Semaglutide is a polypeptide and is metabolized to amino acids by serum and tissue proteases and is unlikely to have any direct hepatotoxic potential. One possibility is that acute hepatic injury on semaglutide therapy represents acute onset of biliary obstruction from a gallstone as it passes through the common bile duct. The initial serum enzyme pattern from acute biliary obstruction can be hepatocellular, but within days transitions to a mixed or cholestatic pattern. Semaglutide acts through the incretin pathway to affect glucose metabolism and, thus, is often grouped with other incretin-based antidiabetic mediations such as the DPP-4 inhibitors such as sitagliptin and other GLP-1 analogues such as exenatide.

### Outcome and Management

The product label for semaglutide does not recommend routine monitoring of liver tests during therapy. Because of the reports of acute liver injury with its use, however, semaglutide should be at least temporarily discontinued if serum aminotransferase levels are found to rise above 5 times the ULN or for any ALT elevations accompanied by symptoms of liver disease or jaundice. Patients presenting with new onset hepatic or hepatobiliary injury should have careful assessment of the biliary tree by ultrasound or magnetic resonance imaging with contrast.

Drug Class: Antidiabetic Agents, Weight Loss Agents

Other Drugs in the Subclass, Incretin-Based Drugs, Glucagon-Like Peptide-1 (GLP-1) Analogues: Albiglutide, Dulaglutide, Exenatide, Liraglutide, Lixisenatide, Tirzepatide

## CASE REPORT

### Case 1. Progressive cholestatic hepatitis causing cirrhosis attributed to semaglutide.(1)

A 51 year old Asian American man with diabetes, chronic renal disease, hypertension, hyperlipidemia, and nonalcoholic fatty liver disease with mild serum ALT and AST elevations was treated with oral semaglutide for his type 2 diabetes. One month after starting, he was found to have a rise in serum alkaline phosphatase (Alk P: 431 U/L) without symptoms and with no change in serum aminotransferase or bilirubin levels (Table). He had no history of hepatitis or jaundice, did not drink alcohol, and had no risk factors for viral hepatitis. His other medications included pitavastatin and ibuproben, which with semaglutide were stopped. The INR was normal. Serum creatinine was 2.9 mg/dL. Tests for hepatitis A, B, C, and COVID 19 were negative, as were autoantibodies including ANA, SMA and ANA. Abdominal magnetic resonance imaging with cholangiogram were normal without evidence of biliary obstruction or gallstones. In follow up he remained jaundiced with prominent elevations in Alk P and mild to moderate elevations in ALT and AST. Repeat imaging with ERCP was normal. He underwent two liver biopsies both of which showed marked bile duct injury, mild cholestasis, and damage to interlobular bile ducts, but no bile duct loss. His renal disease worsened, and required hemodialysis. Two years after onset of the liver disease he underwent successful combined liver and kidney transplantation.

#### Key Points

Medication: | Oral Semaglutide (7 mg daily)
Pattern: | Cholestatic (R = 0.5)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 6 months
Recovery: | Incomplete, chronicity
Other medications: | Insulin, Pitavastatin, Ibuprofen, multivitamins

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | 0 | 68 | 159 | 1.1
27 days | 0 | 69 | 431 | 0.8
190 days | 0 | 137 | 688 | 2.6 | Semaglutide stopped
202 days | 2 weeks | 123 | 763 | 4.2 | INR 1.0, Liver biopsy
210 days | 1 month | 67 | 609 | 3.0
259 days | 2 months | 95 | 653 | 2.9 | INR 1.0
294 days | 4 months | 101 | 714 | 7.1 | INR 1.16
380 days | 6 months | 42 | 603 | 3.9
496 days | 10 months | 51 | 491 | 1.8
559 days | 12 months | 45 | 500 | 1.8
612 days | 14 months | 66 | 693 | 5.0
643 days | 15 months | 31 | 489 | 3.2
707 days | 17 months | 73 | 545 | 6.4 | Liver & Renal Transplant
Upper Limit of Normal | | 45 | 125 | 1.2

#### Comment

A middle aged man with diabetes and nonalcoholic fatty liver disease, who had pre-existing mild liver test abnormalities, developed jaundice 6 months after starting oral semaglutide which persisted despite prompt stopping of the drug. No other cause of the acute cholestatic hepatitis was identified which evolved into chronic cholestatic injury which was also was unexplained. There was neither bile duct loss nor evidence of chronic biliary obstruction. Nevertheless, the chronic injury eventually led to liver transplantation. Progressive unexplained cholestasis after an acute drug-induced cholestatic hepatitis can occur but is very rare. Most cases with these clinical manifestations are due to vanishing bile duct syndrome. In this case follow up liver biopsies demonstrated persistent bile duct inflammation and injury without duct loss. On expert adjudication this case was scored as “probable” with a possible alternative diagnosis of small duct sclerosing cholangitis.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Semaglutide [for diabetes] – Ozempic®, Rybelsus®

Semaglutide [for weight loss] – Wegovy®

DRUG CLASS

Antidiabetic Agents, Weight Loss Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Semaglutide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Semaglutide | 910463-68-2 | Protein | Complex Polypeptide

## CITED REFERENCE

1 Ma J, Mathur K, Muldoon JL, Ghabril M, Chalasani N, Vuppalanchi R. Progressive cholestasis and biliary cirrhosis after initiating oral semaglutide: report from the Drug-Induced Liver Injury Network. ACG Case Rep J. 2022;9: e00922..36600793

## ANNOTATED BIBLIOGRAPHY

References updated: 20 June 2025

Abbreviations used: GLP-1, glucagon-like polypeptide-1; sc, subcutaneously; HbA1c, hemoglobin A1c; FAERS, FDA’s Adverse Event Reporting System.

Zimmerman HJ. Oral hypoglycemic agents and other diabetes therapy. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 575-9. (Textbook of hepatotoxicity published in 1999 and before the availability of GLP-1 analogues).
De Marzio DH, Navarro VJ. Antidiabetic drugs. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 528-30. (Review of hepatotoxicity of antidiabetic drugs; mentions that there have been no published reports of hepatotoxicity of the GLP-1 analogues).
Powers AC, D'Alessio D. Endocrine pancreas and pharmacotherapy of diabetes mellitus and hypoglycemia. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 863-86. (Textbook of pharmacology and therapeutics; discusses glucagon-like peptide-1 and the incretin pathway and agents that act on this pathway).
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2017/209637Orig1s000MedR.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application of semaglutide for diabetes [Ozempic] for safety and efficacy; mentions that mean levels of ALT and AST usually decrease on semaglutide therapy probably as a result of weight loss and that ALT elevations during therapy are no more frequent than with placebo or comparator arms, rising to above 5 times ULN in 0.5% or less).
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/215256Orig1s000MedR.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy of semaglutide for weight loss (Wegovy), mentions that semaglutide has been implicated in at least ten cases of suspected drug-induced live injury and that among 2650 patients treated with maintenance semaglutide vs 1529 placebo recipients, “hepatic disorder events arose in 2.3% vs 2.7%”, and in another pooled analysis, ALT elevations arose in 5.2% vs 8.3% and were above 5 times ULN in <0.1% of both groups).
Marso SP, Bain SC, Consoli A, Eliaschewitz FG, Jódar E, Leiter LA, Lingvay I, et al.; SUSTAIN-6 Investigators. Semaglutide and cardiovascular outcomes in patients with type 2 diabetes. N Engl J Med 2016; 375: 1834-44. (Among 3297 adults with type 2 diabetes on standard regimens treated with addition of semaglutide [0.5 or 1.0 mg] or placebo injections weekly for two years, nonfatal myocardial infarction and stroke were less in semaglutide treated subjects, while cardiovascular death rates were similar and gastrointestinal adverse events [51-52% vs 35-36%] and discontinuations [11.5-14.5% vs 5.7-7.6%] were more frequent; no mention of ALT elevations or hepatotoxicity). 27633186
Davies M, Pieber TR, Hartoft-Nielsen ML, Hansen OKH, Jabbour S, Rosenstock J. Effect of oral semaglutide compared with placebo and subcutaneous semaglutide on glycemic control in patients with type 2 diabetes: a randomized clinical trial. JAMA 2017; 318: 1460-70. (Among 632 patients with type 2 diabetes and inadequate glycemic control on metformin treated with oral semaglutide [2.5, 5, 10, 20 or 40 mg] or placebo vs once weekly sc semaglutide for 26 weeks, glycemic control and weight loss were more frequent with oral semaglutide than placebo and, at higher doses, similar to that of semaglutide given sc; no mention of ALT elevations or hepatotoxicity). 29049653
Ahrén B, Masmiquel L, Kumar H, Sargin M, Karsbøl JD, Jacobsen SH, Chow F. Efficacy and safety of once-weekly semaglutide versus once-daily sitagliptin as an add-on to metformin, thiazolidinediones, or both, in patients with type 2 diabetes(SUSTAIN 2): a 56-week, double-blind, phase 3a, randomised trial. Lancet Diabetes Endocrinol 2017; 5: 341-54. (Among 1231 patients with type 2 diabetes with inadequate glycemic control on oral agents with addition of semaglutide [0.5 mg or 1.0 mg weekly] improved HbA1c levels more than sitagliptin [100 mg daily], but was associated with higher rates of gastrointestinal adverse events and discontinuations [8%-10% vs 3%]; no mention of ALT elevations or hepatotoxicity). 28385659
Aroda VR, Bain SC, Cariou B, Piletič M, Rose L, Axelsen M, Rowe E, DeVries JH. Efficacy and safety of once-weekly semaglutide versus once-daily insulin glargine as add-on to metformin (with or without sulfonylureas) in insulin-naive patients with type 2 diabetes (SUSTAIN 4): a randomised, open-label, parallel-group, multicentre, multinational, phase 3a trial. Lancet Diabetes Endocrinol 2017; 5: 355-66. (Among 1089 patients with type 2 diabetes with inadequate control on metformin treated with semaglutide sc once weekly or insulin daily for 30 weeks, HbA1c levels improved more with semaglutide while hypoglycemic episodes were less, although gastrointestinal adverse events were greater; no mention of ALT elevations or hepatotoxicity). 28344112
Blundell J, Finlayson G, Axelsen M, Flint A, Gibbons C, Kvist T, Hjerpsted JB. Effects of once-weekly semaglutide on appetite, energy intake, control of eating, food preference and body weight in subjects with obesity. Diabetes Obes Metab 2017; 19: 1242-51. (Among 30 obese subjects treated with once weekly semaglutide or placebo given sc, weight loss was greater with semaglutide [-5 kg vs + 1 kg]; no mention of ALT elevations or hepatotoxicity). 28266779
Sorli C, Harashima SI, Tsoukas GM, Unger J, Karsbøl JD, Hansen T, Bain SC. Efficacy and safety of once-weekly semaglutide monotherapy versus placebo in patients with type 2 diabetes (SUSTAIN 1): a double-blind, randomised, placebo-controlled, parallel-group, multinational, multicentre phase 3a trial. Lancet Diabetes Endocrinol 2017; 5: 251-60. (Among 381 patients with type 2 diabetes not controlled with diet and exercise, sc semaglutide led to better glycemic control and more weight loss than placebo, although gastrointestinal side effects were greater [38% vs 15%]; no mention of ALT elevations or hepatotoxicity). 28110911
Ahmann AJ, Capehorn M, Charpentier G, Dotta F, Henkel E, Lingvay I, Holst AG, et al. Efficacy and safety of once-weekly semaglutide versus exenatide ER in subjects with type 2 diabetes (SUSTAIN 3): a 56-week, open-label, randomized clinical trial. Diabetes Care 2018; 41: 258-66. (Among 813 adults with type 2 diabetes with inadequate glycemic control on oral agents treated with addition of semaglutide [1.0 mg] or exenatide ER [2.0 mg] weekly, HbA1c levels and body weight decreased more with semaglutide while adverse event rates were similar, nausea being more frequent with semaglutide [22% vs 12%], but injection site reactions with exenatide [0% vs 12%]; no mention of ALT elevations or hepatotoxicity). 29246950
O'Neil PM, Birkenfeld AL, McGowan B, Mosenzon O, Pedersen SD, Wharton S, Carson CG, et al. Efficacy and safety of semaglutide compared with liraglutide and placebo for weight loss in patients with obesity: a randomised, double-blind, placebo and active controlled, dose-ranging, phase 2 trial. Lancet 2018; 392(10148): 637-49. (Among 957 patients with obesity treated with semaglutide in 4 doses or liraglutide in 1 dose or placebo given daily for 52 weeks, weight loss was 2.4-6.2 kg with semaglutide, 8.5 kg for liraglutide and 2.5 kg for placebo, while gastrointestinal adverse events were more common with the GLP-1 analogues [62-82% vs 38%] and “hepatic events” were less [0-3% vs 7%] and none were considered serious). 30122305
Kluger AY, McCullough PA. Semaglutide and GLP-1 analogues as weight-loss agents. Lancet 2018; 392 (10148): 615-6. (Editorial in response to O’Neil [2018] on use of GLP-1 analogues and other antidiabetic medications as weight loss agents, the major reservation being gastrointestinal side effects and poor tolerance). 30122306
Lingvay I, Desouza CV, Lalic KS, Rose L, Hansen T, Zacho J, Pieber TR. A 26-week randomized controlled trial of semaglutide once daily versus liraglutide and placebo in patients with type 2 diabetes suboptimally controlled on diet and exercise with or without metformin. Diabetes Care 2018; 41: 1926-37. (Among 705 patients with type 2 diabetes not controlled with metformin treated with semaglutide or liraglutide or placebo given subcutaneously [sc] daily for 26 weeks, glycemic control was better with the GLP-1 analogues than placebo, while gastrointestinal adverse events were more common; no mention of ALT elevations or hepatotoxicity). 30026333
Tuchscherer RM, Thompson AM, Trujillo JM. Semaglutide: the newest once-weekly GLP-1 RA for type 2 diabetes. Ann Pharmacother 2018; 52: 1224-32. (Review of the mechanism of action, pharmacokinetics, clinical efficacy, safety and ongoing research on semaglutide as therapy of diabetes, obesity and nonalcoholic fatty liver; no mention of ALT elevations or hepatotoxicity). 29932006
Baekdal TA, Thomsen M, Kupčová V, Hansen CW, Anderson TW. Pharmacokinetics, safety, and tolerability of oral semaglutide in subjects with hepatic impairment. J Clin Pharmacol 2018; 58: 1314-23. (In a pharmacokinetic study of 10 days of oral semaglutide in 32 patients with mild-to-severe hepatic dysfunction and 24 healthy controls, peak and area under-the-curve plasma concentrations were similar in all groups as was plasma half-life, and adverse event rates were similar). 29693715
Rodbard HW, Lingvay I, Reed J, de la Rosa R, Rose L, Sugimoto D, Araki E, et al. Semaglutide added to basal insulin in type 2 diabetes (SUSTAIN 5): a randomized, controlled trial. J Clin Endocrinol Metab 2018; 103: 2291-301. (Among 397 patients with type 2 diabetes not controlled with insulin and metformin treated with semaglutide or placebo sc once weekly for 30 weeks, HbA1c levels improved with semaglutide [-1.4% and -1.8%] but not with placebo [-0.1%], while gastrointestinal adverse events were more with semaglutide; no mention of ALT elevations or hepatotoxicity). 29688502
Pratley RE, Aroda VR, Lingvay I, Lüdemann J, Andreassen C, Navarria A, Viljoen A; SUSTAIN 7 investigators. Semaglutide versus dulaglutide once weekly in patients with type 2 diabetes (SUSTAIN 7): a randomised, open-label, phase 3b trial. Lancet Diabetes Endocrinol 2018; 6: 275-86. (Among 1201 patients with type 2 diabetes and inadequate glycemic control on metformin treated with semaglutide or dulaglutide sc once weekly for 40 weeks, semaglutide led to greater improvements in glycemic control while adverse even rates were similar; no mention of ALT elevations or hepatotoxicity). 29397376
Semaglutide (Ozempic)--another injectable GLP-1 receptor agonist for type 2 diabetes. Med Lett Drugs Ther 2018; 60 (1539): 19-21. (Concise review of the mechanism of action, clinical efficacy, safety and costs of semaglutide shortly after its approval in the US; mentions common adverse events of nausea, vomiting, diarrhea, constipation and abdominal pain as well as skin hypersensitivity reactions, but does not mention ALT elevations or hepatotoxicity). 29364197
Newsome PN, Buchholtz K, Cusi K, Linder M, Okanoue T, Ratziu V, Sanyal AJ, et al.; NN9931-4296 Investigators. A placebo-controlled trial of subcutaneous semaglutide in nonalcoholic steatohepatitis. N Engl J Med. 2021;384:1113-1124.. (Among 320 adults with nonalcoholic steatohepatitis [NASH] and hepatic fibrosis treated with semaglutide [0.1, 0.2, or 0.4 mg] vs placebo given subcutaneously once daily for 72 weeks, resolution of NASH occurred in 36% to 59% vs 17% while adverse events arose in 90% to 97% vs 80% and were serious in 15% to 19% vs 10%, but “hepatic events were similar across all treatment groups”, and there was no mention of suspected drug-induced liver injury). 33185364
Ma J, Mathur K, Muldoon JL, Ghabril M, Chalasani N, Vuppalanchi R. Progressive cholestasis and biliary cirrhosis after initiating oral semaglutide: report from the Drug-Induced Liver Injury Network. ACG Case Rep J. 2022;9: e00922.. (51 year old man with diabetes and NASH with mild chronic ALT elevations developed jaundice 6 months after starting 7 mg of oral semaglutide daily [bilirubin 3.2 mg/dL, ALT 96 U/L, Alk P 455 U/L] with associated renal dysfunction and persistence of jaundice and creatinine elevations ultimately undergoing both liver and kidney transplantation several years later). 36600793
Liang Y, Zhang Z, Zheng J, Wang Y, He J, Zhao J, Su L. Association of incretin-based therapies with hepatobiliary disorders among patients with type 2 diabetes: a case series from the FDA Adverse Event Reporting System. Endocr Connect. 2024;13: e240404.. (Between 2006 and 2023, 1327 reports of liver injury attributed to incretin-based therapies were received by the FDA Adverse Event Reporting System [FAERS], including 669 due to GLP-1 agonists almost all of which were attributed to cholelithiasis or cholecystitis). 39404734
Sanyal AJ, Newsome PN, Kliers I, Østergaard LH, Long MT, Kjær MS, Cali AMG, et al.; ESSENCE Study Group. Phase 3 trial of semaglutide in metabolic dysfunction-associated steatohepatitis. N Engl J Med. 2025;392:2089-2099.. (Among 800 adults with nonalcoholic steatohepatitis [NASH] and fibrosis treated with subcutaneous semaglutide [2.4 mg] vs placebo once weekly for 72 weeks, resolution of NASH occurred in 63% vs 34% reduction of fibrosis in 37% vs 22%, while adverse events arose in 86% vs 79% that were serious in 13.4% of both groups and serum ALT levels decreased more with semaglutide and “hepatic injury” was reported in 3.6% vs 6.3%). 40305708
Aronne LJ, Horn DB, le Roux CW, Ho W, Falcon BL, Gomez Valderas E, Das S, et al; SURMOUNT-5 Trial Investigators. Tirzepatide as compared with semaglutide for the treatment of obesity. N Engl J Med. 2025 May 11. Epub ahead of print.. (Among 781 obese adults without diabetes treated with tirzepatide vs semaglutide for 72 weeks, weight loss was greater with tirzepatide [-20% vs -14%] while both overall [77% vs 79%] and serious events [4.8% vs 3.5%] were similar; no mention of ALT elevations or hepatic adverse events). 40353578

## OTHER REFERENCE LINKS

1. Recent References on Semaglutide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Semaglutide/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Semaglutide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Semaglutide)